# Entrectinib

## OVERVIEW

### Introduction

Entrectinib is an oral selective inhibitor of the neurotrophic T receptor kinase (NTRK) and ROS1 that is used to treat solid tumors with NTRK gene fusion and non-small cell lung cancer with ROS1 mutations. Serum aminotransferase elevations are common during therapy but clinically apparent liver injury is rare, although it has been reported.

### Background

Entrectinib (en trek’ ti nib) is an orally available, small molecule inhibitor of the tropomyosin receptor kinase (TRK) which encodes the neurotrophic T receptor kinase (NTRK) 1, 2 and 3. Entrectinib also inhibits c-ros oncogene 1 (ROS1), a receptor tyrosine kinase and proto-oncogene expressed in several tumors, and the anaplastic lymphoma kinase (ALK) and has central nervous system activity. NTRK mutations are common in some very rare forms of cancer (infantile fibrosarcoma, congenital mesoblastic nephroma) and are infrequent in some common cancers (urothelial, pancreatic, lung and breast cancer). Entrectinib was found to be a potent inhibitor of cell growth and proliferation in tumor cell lines and experimental tumor models with NTRK fusion genes and has shown activity based upon the molecular target and gene protein profile rather than the organ involved or histologic form of cancer. Entrectinib has been approved in the United States and elsewhere for solid tumors with documented NTRK fusion genes and for non-small cell lung cancer with ROS-1 mutations. Entrectinib was approved for use in 2019 in the United States as therapy for adults with NSCLC and ROS1 gene mutations and for adults and children (aged 12 years or older) with advanced, unresectable or metastatic solid tumors harboring NTRK mutations. Entrectinib is available in capsules of 100 and 200 mg under the brand name Rozlytek. The recommended dose is 600 mg once daily in adults and 400 mg to 600 mg in children based upon body surface area. Side effects are common and arise in almost all patients treated with entrectinib and can include dysgeusia, diarrhea, weight gain, paresthesias, myalgias, arthralgias, edema, anemia, elevations in serum creatinine, uric acid, and aminotransferase levels. Uncommon but potentially severe adverse events include congestive heart failure, skeletal fractures, cognitive dysfunction, mood disorders, prolongation of the QT interval, visual disorders and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of entrectinib in patients with NTRK fusion gene positive solid tumors and ROS1 fusion gene positive non-small cell lung cancer, liver test abnormalities were frequent although usually mild. Some degree of ALT elevation arose in 38% of entrectinib treated patients, but were above 5 times the upper limit of normal (ULN) in only 2% to 3% (although the incidence may have been underestimated as 4.5% of patients had no post-treatment liver function tests). In these trials that enrolled approximately 355 patients, entrectinib was discontinued early due to increased AST or ALT in 0.8% of patients. Thus, in preregistration trials of entrectinib there were no instances of clinically apparent liver injury with jaundice, but therapy was associated with a high rate of serum ALT elevations and the total clinical experience with its use has been limited. The product label for entrectinib recommends monitoring for routine liver tests before, at 2 week intervals during the first month of therapy, and monthly thereafter as clinically indicated.

Likelihood score: E* (unproven but suspect rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury from entrectinib is unknown, but the pattern of abnormalities suggests some degree of low level, direct hepatotoxicity. Entrectinib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4, and is susceptible to drug-drug interactions with agents that inhibit or induce the CYP enzyme reactivity.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation of entrectinib therapy. In patients with clinically apparent liver injury and jaundice, restarting therapy should be done with caution. Cross sensitivity to liver injury is uncommon among the tyrosine kinase inhibitors but there is no information or shared adverse event sensitivity of entrectinib with other antineoplastic protein kinase inhibitors.

Drug Class: Antineoplastic Agents, Tyrosine Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Entrectinib – Rozlytrek®

DRUG CLASS

Antineoplastic Agents, Kinase Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Entrectinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Entrectinib | 1108743-60-7 | C31-H34-F2-N6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 15 September 2021

Abbreviations: ALK, anaplastic lymphoma kinase; NSCLC, non-small cell lung cancer; NTRK, neurotrophic T receptor kinase; ROS1, c-ros oncogene 1.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss entrectinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/212725Orig1s000,%20212726Orig1s000MultidisciplineR.pdf (FDA website with product labels and initial clinical review of the safety and efficacy of entrectinib; states that virtually all patients treated with entrectinib [n=355] had at least one adverse event, 39% had a serious adverse event, 38% of patients had an ALT elevation but only 2.9% were above 5 times ULN and there were no severe hepatic adverse events or instances of clinically apparent liver injury).
Ardini E, Menichincheri M, Banfi P, Bosotti R, De Ponti C, Pulci R, Ballinari D, et al. (2016). Entrectinib, a pan-TRK, ROS1, and ALK inhibitor with activity in multiple molecularly defined cancer indications. Mol Cancer Ther. (Review of the molecular targets of the multi-kinase inhibitor entrectinib with has activity against tumors with fusion genes involving all NTRK-1, -2 and -3 and demonstrated inhibitory activity in cell culture and animal models and is undergoing early phase studies in patients with solid tumors with NTRK gene fusions).
Drilon A, Siena S, Ou SI, Patel M, Ahn MJ, Lee J, Bauer TM, et al. (2017). Safety and antitumor activity of the multitargeted pan-TRK, ROS1, and ALK inhibitor entrectinib: combined results from two phase I trials (ALKA-372-001 and STARTRK-1). Cancer Discov. (Open label study of entrectinib in 119 patents with solid tumors using different dosing schedules found objective responses only in patients with a fusion gene involving NTRK1/2/3, ROS1 or ALK and side effects included fatigue in 46%, dysgeusia 42%, paresthesias 29%, nausea 28%, myalgias 23%, and diarrhea 19%, with dose reductions in 15% and two dose-limiting reactions [800 mg daily]: impaired cognition and eosinophilic myocarditis; no mention of hepatotoxicity or ALT elevations).
Al-Salama ZT, Keam SJ. (2019). Entrectinib: first global approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of entrectinib shortly after its initial approval [in Japan], mentions that ALT elevations arose in only 1% of patients).
Doebele RC, Drilon A, Paz-Ares L, Siena S, Shaw AT, Farago AF, Blakely CM, et al. (2020). trial investigators. Entrectinib in patients with advanced or metastatic NTRK fusion-positive solid tumours: integrated analysis of three phase 1-2 trials. Lancet Oncol. (Analysis of an integrated database from 3 open label trials of entrectinib for NTRK gene fusion positive solid tumors reported an objective response rate of 57% [among 59 adults] and serious adverse event rate of 9% [among 68 patients] , rate of ALT elevation of 9%, and ALT elevation above 2000 U/L in one patient).
Drilon A, Siena S, Dziadziuszko R, Barlesi F, Krebs MG, Shaw AT, de Braud F, et al. (2020). trial investigators. Entrectinib in ROS1 fusion-positive non-small-cell lung cancer: integrated analysis of three phase 1-2 trials. Lancet Oncol. (Among 53 patients with ROS1 fusion positive NSCLC treated with entrectinib [600 mg daily], the objective response rate was 77% [6% complete] including intracranial tumors, while most patients had at least one adverse event and including 10% with ALT elevations [5 times ULN in 2%], but there were no hepatic severe adverse events, or discontinuations or deaths attributable to liver injury).
Sartore-Bianchi A, Pizzutilo EG, Marrapese G, Tosi F, Cerea G, Siena S. (2020). Entrectinib for the treatment of metastatic NSCLC: safety and efficacy. Expert Rev Anticancer Ther. (Review of the mechanism of action, clinical efficacy and safety of entrectinib in patients with non-small cell lung cancer [NSCLC] with ROS1 fusion gene, which in open-label studies had an objective response rate of 77% [6% complete] and adverse reactions included AST elevations in 10% that were greater than 5 times ULN in only 1%).
Marcus L, Donoghue M, Aungst S, Myers CE, Helms WS, Shen G, Zhao H, et al. (2021). FDA approval summary: entrectinib for the treatment of NTRK gene fusion solid tumors. Clin Cancer Res. (Summary of data on efficacy and safety of entrectinib as therapy of NTRK gene fusion positive solid tumors based on 54 patients with various tumors [including sarcoma, NSCLC, breast, colorectal, thyroid and pancreatic cancers] with an objective response rate of 57% [7% complete] and duration of response of 3-26 months, and adverse events in almost all patients, including 39% with serious adverse events; no discussion of hepatotoxicity or ALT elevations).
Delgado J, Pean E, Melchiorri D, Migali C, Josephson F, Enzmann H, Pignatti F. (2021). The European Medicines Agency review of entrectinib for the treatment of adult or paediatric patients with solid tumours who have a neurotrophic tyrosine receptor kinase gene fusions and adult patients with non-small-cell lung cancer harbouring ROS1 rearrangements. ESMO Open. (Summary of the data on efficacy and safety of entrectinib therapy that supported its marketing approval by the European Medicines Agency based upon results from 3 open-label studies demonstrating an objective response rate of 64% [complete in 7%] with an overall survival of 23.9 months, but a high rate of adverse events [99.4%], including serious adverse events [40%], requiring discontinuation in 9%, liver abnormalities in 22.6% but no liver related deaths).

## OTHER REFERENCE LINKS

1 Recent References on Entrectinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Entrectinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Entrectinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Entrectinib)